# Tralokinumab

## OVERVIEW

### Introduction

Tralokinumab is a human monoclonal antibody to IL-13 which is used to treat atopic dermatitis. Tralokinumab is generally well tolerated and has not been linked to elevations in serum aminotransferase levels during therapy or to instances of clinically apparent liver injury.

### Background

Tralokinumab (tral’ oh kin’ ue mab) is a human monoclonal IgG4 antibody directed against IL-13, a major mediator of chronic inflammation and which is over-expressed and a dominant cytokine in lesional skin cells in atopic dermatitis. Tralokinumab has been assessed in several chronic inflammatory diseases, including asthma, chronic bronchitis, idiopathic pulmonary fibrosis, and ulcerative colitis, and while demonstrating little positive benefit in these conditions, was found to be well tolerated with adverse event rates similar to those with placebo. In contrast, preregistration randomized, placebo controlled trials of tralokinumab in patient with moderate-to-severe atopic dermatitis demonstrated significant response rates with tralokinumab alone as well as in combination with topical corticosteroids. Clinical responses were generally maintained with long term therapy. Tralokinumab was approved in the United States in 2021 for adults with moderate-to-severe atopic dermatitis whose disease is not adequately controlled with topical prescription therapies. Tralokinumab is available in single dose pre-filled syringes of 150 mg in 1 mL under the brand name Adbry. The recommended regimen is an initial dose of 600 mg (4 syringes) subcutaneously followed by 300 mg (two syringes) every other week, which can be extended to every 4 weeks with long term use. Common side effects include mild local injection reactions, nasopharyngitis, fatigue, headache, arthralgia, skin rashes, conjunctivitis and eosinophilia. Uncommon, potentially severe adverse reactions include hypersensitivity reactions, keratitis, parasitic infections and risk of infection with viruses found in live attenuated vaccines.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations arise in less than 1% of patients treated with tralokinumab, and such abnormalities are generally transient, asymptomatic, and rarely necessitate drug discontinuation. In most trials, serum ALT elevations occurred at similar rates in placebo recipients. In large, preregistration trials there were no instances of clinically apparent liver injury or severe hepatic adverse events attributed to tralokinumab. Since its approval and more general use, there have been no reports of clinically significant liver injury attributed to tralokinumab. Whether reactivation of hepatitis B might occur with tralokinumab therapy has yet to be reported. It has been associated with reactivation of herpes zoster.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

The possible mechanisms of liver injury due to tralokinumab are unclear. Monoclonal antibodies and immunoglobulins are generally taken up and metabolized intracellularly to short peptides and amino acids. There is no evidence to suggest that inhibition of IL-13 signaling would trigger liver injury or autoimmune liver conditions.

Drug Class: Dermatologic Agents, Monoclonal Antibodies

Other Drugs for Atopic Dermatitis: Dupilumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tralokinumab – Adbry®

DRUG CLASS

Dermatologic Agents, Atopic Dermatitis

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tralokinumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tralokinumab | 1044515-88-9 (https://pubchem.ncbi.nlm.nih.gov/substance/135339998) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 23 January 2023

FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/761180Orig1s000IntegratedR.pdf (Multidisciplinary FDA review of tralokinumab in support of its approval for use in atopic dermatitis mentions that two patients in trials of tralokinumab for atopic dermatitis developed elevations of ALT and jaundice, but neither was considered treatment related and liver enzymes overall remained within the normal range).
Danese S, Rudziński J, Brandt W, Dupas JL, Peyrin-Biroulet L, Bouhnik Y, Kleczkowski D, et al. (2015). Tralokinumab for moderate-to-severe UC: a randomised, double-blind, placebo-controlled, phase IIa study. Gut. (Among 111 patients with ulcerative colitis treated with tralokinumab or placebo subcutaneously every 2 weeks for 12 weeks, clinical response rates were similar [38% vs 33%] as were adverse event rates [75% vs 71%] and most severe adverse events were due to ulcerative colitis; no mention of ALT elevations or hepatotoxicity).
Russell RJ, Chachi L, FitzGerald JM, Backer V, Olivenstein R, Titlestad IL, Ulrik CS, et al., MESOS study investigators. (2018). Effect of tralokinumab, an interleukin-13 neutralising monoclonal antibody, on eosinophilic airway inflammation in uncontrolled moderate-to-severe asthma (MESOS): a multicentre, double-blind, randomised, placebo-controlled phase 2 trial. Lancet Respir Med. (Among 79 adults with moderate-to-severe asthma treated with tralokinumab [300 mg] or placebo subcutaneously every 2 week for 12 weeks, there were no differences in response rates between the two groups and adverse event rates were similar [85% vs 80%]).
Panettieri RA, Sjöbring U, Péterffy A, Wessman P, Bowen K, Piper E, Colice G, Brightling CE. (2018). Tralokinumab for severe, uncontrolled asthma (STRATOS 1 and STRATOS 2): two randomised, double-blind, placebo-controlled, phase 3 clinical trials. Lancet Respir Med. (Among more than 2000 patients with severe, uncontrolled asthma treated with tralokinumab [300 mg] or placebo subcutaneously every 2 or 4 weeks for 52 weeks in two controlled trials, there were no differences in the annualized rates of asthma exacerbations between treatment groups and both total and severe adverse event rates were similar in all groups, although discontinuations for adverse events were more frequent with tralokinumab; no mention of ALT elevations or hepatotoxicity).
Silverberg JI, Toth D, Bieber T, Alexis AF, Elewski BE, Pink AE, Hijnen D, et al. (2021). ECZTRA 3 study investigators. Tralokinumab plus topical corticosteroids for the treatment of moderate-to-severe atopic dermatitis: results from the double-blind, randomized, multicentre, placebo-controlled phase III ECZTRA 3 trial. Br J Dermatol. (Among 380 adults with moderate-to-severe atopic dermatitis treated with as needed topical corticosteroids and either tralokinumab [300 mg] or placebo subcutaneously every 2 weeks for 16 weeks, with subsequent re-randomization and continuation for another 16 weeks, clinical response rates were higher with tralokinumab and increased with duration of therapy, while overall and severe adverse event rates were similar in both groups [71% vs 67%] and there were no noteworthy differences in laboratory values except for increases in eosinophils during early therapy with tralokinumab).
Wollenberg A, Blauvelt A, Guttman-Yassky E, Worm M, Lynde C, Lacour JP, Spelman L, et al. (2021). ECZTRA 1 and ECZTRA 2 study investigators. Tralokinumab for moderate-to-severe atopic dermatitis: results from two 52-week, randomized, double-blind, multicentre, placebo-controlled phase III trials (ECZTRA 1 and ECZTRA 2). Br J Dermatol. (Among 1596 adults with moderate-to-severe atopic dermatitis treated with tralokinumab [300 mg, after a loading dose of 600 mg] or placebo every two weeks for 16 weeks with re-randomization to 52 weeks in two controlled trials, clinical response rates at 16 weeks were higher with tralokinumab [16% and 22%] than placebo [7% and 11%], while total and severe adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
Duggan S. (2021). Tralokinumab: first approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of tralokinumab shortly after its approval for use in atopic dermatitis in the US mentions that total and severe adverse events were similar in tralokinumab- and placebo-treated groups and that most drug related adverse events were mild and transient including conjunctivity [5.4%], eosinophilia [1.3%] and injection site reactions [7.2%]; no mention of hepatotoxicity or ALT elevations).
Blauvelt A, Langley RG, Lacour JP, Toth D, Laquer V, Beissert S, Wollenberg A, et al. (2022). Long-term 2-year safety and efficacy of tralokinumab in adults with moderate-to-severe atopic dermatitis: Interim analysis of the ECZTEND open-label extension trial. J Am Acad Dermatol. (Among 345 patients with moderate-to-severe atopic dermatitis who had participated in controlled trials of tralokinumab and then continued in extension studies for at least 2 years, no new safety signals were seen; no mention of ALT elevations or hepatoxicity).
Simpson EL, Merola JF, Silverberg JI, Reich K, Warren RB, Staumont-Sallé D, Girolomoni G, et al. (2022). Safety of tralokinumab in adult patients with moderate-to-severe atopic dermatitis: pooled analysis of five randomized, double-blind, placebo-controlled phase II and phase III trials. Br J Dermatol. (In a pooled analysis of 2285 patients with atopic dermatitis in 5 randomized placebo-controlled trials of tralokinumab, adverse event rates were similar with the two groups [66% vs 67%], as were severe adverse events [2.1% vs 2.8%], and specific symptoms more frequent with tralokinumab included upper respiratory infections [16% vs 12%], conjunctivitis [5.4% vs 1.9%], injection site reactions [3.5% vs 0.3%], eosinophilia [22% vs 9%], but not ALT elevations above 3 times ULN [0.5% vs 0.6%]).

## OTHER REFERENCE LINKS

1 Recent References on Tralokinumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tralokinumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tralokinumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tralokinumab)